# Bitter Melon

## OVERVIEW

### Introduction

Bitter melon is a climbing vine that produces an oblong, green fruit that resembles a cucumber and can be eaten but is very bitter. Extracts of bitter melon fruit have been used in traditional medicine and most recently as a hypoglycemic agent to treat diabetes. Bitter melon extracts have not been associated with serum enzyme elevations during therapy nor have they been implicated in cases of clinically apparent liver injury.

### Background

Bitter melon (Momordica charantia) is a climbing vine found in tropical and subtropical areas that produces a green, deeply ridged or warty oblong fruit resembling a cucumber. The fruit, although quite bitter, can be eaten raw but more frequently is used in cooking or in preparing teas. Extracts of the fruit have also been used in traditional medicine for multiple conditions including constipation, dyspepsia, ulcer disease, cough, respiratory illnesses, gout, arthritis, skin disease and wounds. Claims have been made that bitter melon has antiviral effects which may be beneficial in human immunodeficiency virus (HIV) infection and that it has antineoplastic activities that may be effective for cancer. None of these purported effects, however, have been demonstrated in clinical trials in humans. Studies in animals as well as humans have shown that bitter melon extracts can lower blood sugar for which reason it has been marketed as a treatment of type 2 diabetes. The components of bitter melon responsible for the hypoglycemic effects are not known, but the fruit extracts contain alkaloids, glycosides, saponins, triterpenes, oils, steroids sterols, polysaccharides, resins and proteins, several of which have been shown to have effects on glucose metabolism in cell culture or animal models. The exact mechanism of the hypoglycemic effect of bitter melon is not known. In placebo controlled clinical trials in patients with diabetes or glucose intolerance, bitter melon extracts have had only a modest effect on serum glucose levels and little or no effect on fasting plasma glucose or hemoglobin A1c levels. Bitter melon has not been approved for the treatment of diabetes or any other medical condition in the United States by the FDA. Nevertheless, bitter melon extracts are available over-the-counter as a dietary supplement in multiple forms including liquid, powders and tablets. The typical recommended dose is 500 to 1000 mg taken in two to three times daily. Bitter melon extracts are usually well tolerated, but side effects can include abdominal discomfort, heartburn, constipation or diarrhea, nausea and vomiting, dizziness, headache and hypoglycemia. Rare but potentially severe adverse effects include severe hypoglycemia, coma and seizures. Bitter melon is a potential abortifacient and should not be used in pregnancy or in women of childbearing age not using effective contraception.

### Hepatotoxicity

In multiple, largely short-term clinical studies of different preparations and concentrations of bitter melon extracts, adverse side effects were usually described as uncommon and minimal with either no change or slight improvement in serum aminotransferase levels. Despite wide-spread use, there have been no published reports of serum enzyme elevations or clinically apparent liver injury attributable to bitter melon extracts.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which bitter melon extracts might cause liver injury is unknown.

### Outcome and Management

Hepatotoxicity from extracts of bitter melon fruit or leaves has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Goya, Bitter Apple, Bitter Gourd, Bitter Squash, Balsam Pear.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bitter Melon – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/795.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bitter Melon | 128529-78-2 (https://pubchem.ncbi.nlm.nih.gov/#query=128529-78-2) | Herbal | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 20 March 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not bitter melon extract).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of bitter melon).
Bitter melon. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 405-410. (Compilation of short monographs on herbal medications and dietary supplements).
Basch E, Gabardi S, Ulbricht C. (2003). Bitter melon (Momordica charantia): a review of efficacy and safety. Am J Health Syst Pharm. (Review of the efficacy and safety of bitter melon as therapy for diabetes concludes that it may have hypoglycemic effects, but the data are not sufficient to recommend its use; no mention of ALT elevations or hepatotoxicity in humans treated with bitter melon).
Yeh GY, Eisenberg DM, Kaptchuk TJ, Phillips RS. (2003). Systematic review of herbs and dietary supplements for glycemic control in diabetes. Diabetes Care. (Systematic review of 36 herbs and dietary supplements used for glycemic control in patients with diabetes or glucose intolerance identified 108 trials with 4565 patients but concluded that the data for efficacy was inconclusive, but that few adverse events were reported and that several agents including bitter melon [Momordica charantia] had preliminary promising results).
Dans AM, Villarruz MV, Jimeno CA, Javelosa MA, Chua J, Bautista R, Velez GG. (2007). The effect of Momordica charantia capsule preparation on glycemic control in type 2 diabetes mellitus needs further studies. J Clin Epidemiol. (Among 40 adults with diabetes with elevated hemoglobin A1c [HbA1c] levels despite oral hypoglycemic therapy who were treated with either bitter melon [3 gm daily] or placebo capsules for 3 months, there were no changes in body weight, HbA1c levels or fasting blood glucose levels in either group, while adverse events included diarrhea and abdominal pain, serum ALT and AST declined slightly in both groups).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list bitter melon among products associated with 5 or more reports).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not bitter melon).
Fuangchan A, Sonthisombat P, Seubnukarn T, Chanouan R, Chotchaisuwat P, Sirigulsatien V, Ingkaninan K, et al. (2011). Hypoglycemic effect of bitter melon compared with metformin in newly diagnosed type 2 diabetes patients. J Ethnopharmacol. (Among 129 patients with newly diagnosed diabetes treated with bitter melon [500, 1000 or 2000 mg] or metformin [1000 mg] daily for 4 weeks, fasting and postprandial blood glucose decreased with metformin but not with bitter melon, and adverse events included headache, dizziness, and palpitations, and one patient with preexisting elevations had minor further increases in ALT [from 82 to 102 U/L] and AST levels [from 73 to 105 U/L] on bitter melon [500 mg daily] that resolved with stopping).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not mention or list bitter melon extract).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention bitter melon).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to bitter melon extract).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss bitter melon).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of bitter melon).
Peter EL, Kasali FM, Deyno S, Mtewa A, Nagendrappa PB, Tolo CU, Ogwang PE, et al. (2019). Momordica charantia L. lowers elevated glycaemia in type 2 diabetes mellitus patients: Systematic review and meta-analysis. J Ethnopharmacol. (A metaanalysis of trials of bitter melon extracts in type 2 diabetes identified 10 studies with 1045 patients treated with 2 to 6 gm of bitter melon daily for 4 to 16 weeks, and demonstrated an overall but inconsistent modest improvement in HbA1c and blood glucose levels, while adverse events were generally mild, largely gastrointestinal with diarrhea and abdominal pain, and with no change or mild improvements in serum aminotransferase levels and no treatment related serious adverse events).
Kim SK, Jung J, Jung JH, Yoon N, Kang SS, Roh GS, Hahm JR. (2020). Hypoglycemic efficacy and safety of Momordica charantia (bitter melon) in patients with type 2 diabetes mellitus. Complement Ther Med. (Among 96 Korean patients with diabetes who were treated with bitter melon [2380 mg capsules] or placebo daily for 12 weeks, HbA1c levels did not change with bitter melon therapy and fasting glucose levels improved minimally [-5 mg/dL] and adverse events included anorexia, nausea, abdominal discomfort, and skin rash, but rates were similar with placebo and serum liver enzyme test results did not change).
Majeed M, Majeed A, Nagabhusahnam K, Mundkur L, Paulose S. (2021). A randomized, double-blind clinical trial of a herbal formulation (GlycaCare-II) for the management of type 2 diabetes in comparison with metformin. Diabetol Metab Syndr. (Among 60 patients with newly diagnosed diabetes or glucose intolerance treated with a commercial herbal formulation with bitter melon [but also Cinnamomum cassia, Pterocarpus marsupium, Gymnema sylvestre, Salacia reticulata and Eugenia jambolana] or metformin [500 mg] twice daily for 60 days, fasting blood glucose and HbA1c levels decreased similarly in both groups and there were no adverse events and ALT and AST levels did not change).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; bitter melon was not listed among the 79 implicated products).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while bitter melon is not mentioned).

## OTHER REFERENCE LINKS

1 Recent References on Bitter Melon: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bitter+Melon+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Bitter Melon: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bitter%20Melon)